# Repotrectinib

## OVERVIEW

### Introduction

Repotrectinib is a small molecule inhibitor of the proto-oncogene tyrosine-protein kinase ROS1 and of tropomyosin receptor tyrosine kinases (TRK-A, -B and -C) and is used to treat adults with non-small cell lung cancer. Repotrectinib is associated with a moderate rate of mild transient elevations in serum aminotransferase levels during therapy but has not been linked to episodes of clinically apparent liver injury with jaundice.

### Background

Repotrectinib (re poe trek’ ti nib) is a small molecule inhibitor of the proto-oncogene tyrosine-protein kinase ROS1 and of tropomyosin receptor tyrosine kinases (TRKA, B and C) and is used to treat adults with non-small cell lung cancer (NSCLC). Lung cancer is the leading cause of cancer deaths in the United States and NSCLC accounts for approximately 85% of lung cancer. ROS1 mutations and rearrangements are found in up to 2% of NSCLC cases and is associated with poor survival. The function of ROS1 is not well defined; it appears to be an oncogene and to act through downstream activation of ERK and MAPK pathways. Antineoplastic agents that specifically target ROS1 include crizotinib, entrectinib, and repotrectinib. Repotrectinib has potent activity against both wild type and mutant rearranged ROS1 as well as against several TRK mutants often found in combination with ROS1. In a large, open label study of repotrectinib in patients with ROS1 positive NSCLC, the objective response rate was 79% in tyrosine kinase naïve patients and 38% in those with previous tyrosine kinase therapy. Importantly, responses were seen in some patients with central nervous system metastases. Based upon these results, repotrectinib was approved as therapy for locally advanced or metastatic ROS1-positive NSCLC in 2023. Repotrectinib is available in capsules of 40 and 160 mg under the brand name Augtyro. The recommended dose is 160 mg once daily for 14 days followed by 160 mg twice daily continued until unacceptable tolerance or disease progression. In 2024, indications for repotrectinib were extended to solid tumors that have neurotrophic tyrosine kinase receptor gene fusion and that are locally advanced or metastatic and not amenable to surgical resection. Side effects of repotrectinib are common and include dizziness, dysgeusia, peripheral neuropathy, constipation, nausea, fatigue, muscular weakness, dyspnea, ataxia and cognitive impairment. Less frequent but potentially severe adverse events include severe central nervous system effects, interstitial lung disease, hepatotoxicity, myalgia and CPK elevations, hyperuricemia, skeletal fractures, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure trials of repotrectinib as therapy of ROS1-positive NSCLC, liver test abnormalities were frequent but usually mild-to-moderate in severity and self-limited in duration. ALT elevations arose in 34% and AST in 40% and were above 5 times the ULN in 3.1% and 1.9% of the 264 patients treated in the major registration trial. The median time to onset of aminotransferase elevations was 15 days (range 1 day to 1 year). Dose interruptions for ALT abnormalities were done in 1.1% of patients but permanent discontinuations were rare. There were no enzyme elevations with jaundice or symptoms and no life threatening or fatal instances of liver injury. Since approval and clinically availability of repotrectinib, there have been no published case reports of clinically apparent liver injury with jaundice, but clinical experience with its use has been limited.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations or liver injury from repotrectinib therapy are possibly due to direct toxicity of the ROS1 pathway inhibition, but some are likely related to hepatic metastases from the underlying advanced lung cancer. Repotrectinib is metabolized in the liver largely via CYP 3A4 and is susceptible to drug-drug interactions. Repotrectinib is a CYP 3A inducer that can alter the metabolism of CYP 3A substrates. Furthermore, concomitant use of agents that induce or inhibit CYP 3A4 activity should be avoided during therapy with repotrectinib.

### Outcome and Management

The product label for repotrectinib recommends monitoring of liver tests before therapy, every 2 weeks during the first month, and every month thereafter and as clinically indicated. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to discontinuation until levels fall to less than twice ULN. There is little information on cross reactivity in risk for adverse events, hypersensitivity, or hepatic injury between repotrectinib and other ROS1 inhibitors such as crizotinib and entrectinib. Switching to those agents should be done with caution and with close monitoring.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other ROS1 Inhibitors: Crizotinib, Entrectinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Repotrectinib – Augtyro®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Repotrectinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Repotrectinib | 1802220-02-5 | C18-H18-FN5-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 7 April 2025

Abbreviations: NSCLC, non-small cell lung cancer; ROS1, proto-oncogene tyrosine-protein kinase; ULN, upper limit of the normal range.

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as repotrectinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not repotrectinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Multi-Discipline Review. 2023. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/218213Orig1s000MultidisciplineR.pdf (FDA review of the data on efficacy and safety of repotrectinib in support of its approval for ROS1-positive NSCLC in the US, mentions that liver test abnormalities were frequent in the 264 patients who received repotrectinib in the large open-label, prelicensure clinical trial, ALT elevations arising in 34%, AST in 40%, Alk P in 26%, and rising to above 5 times the upper limit of normal (ULN) in 3.1%, 1.9%, and 2.3% of patients, leading to dose interruptions in 2.8%, but discontinuation due to liver test abnormalities were rare and there were no instances of drug induced liver injury or enzyme elevations accompanied by jaundice).
Spraggs CF, Xu CF, Hunt CM. Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics 2013; 14: 541-54. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; repotrectinib is not discussed). 23556451
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013, before the availability of repotrectinib which is not discussed). 23620168
Drilon A, Camidge DR, Lin JJ, Kim SW, Solomon BJ, Dziadziuszko R, Besse B, et al; TRIDENT-1 Investigators. Repotrectinib in ROS1 fusion-positive non-small-cell lung cancer. N Engl J Med. 2024;390: 118-131. (Among 520 adults with locally advanced or metastatic ROS1-positive NSCLC, 103 were treated in a phase 1 dose-finding study and 416 in a phase 2 optimal dose trial, and of 127 with ROS1 fusion rearrangements, the objective response rate was 79% in tyrosine kinase inhibitor (TKI) naïve patients with a median progression-free survival of 36 months, and was 38% in those with previous TKI therapy with a median progression-free survival of 9 months; 99% of patients had at least one adverse event, 35% had a serious event, 50% had dose interruptions, 7% had discontinuations for adverse events, and 23% had ALT elevations which were greater than 5 times ULN in 2%; no mention of hepatic serious adverse events or hepatotoxicity). 38197815
Dhillon S. Repotrectinib: first approval. Drugs. 2024;84:239-246. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of repotrectinib shortly after its first approval in the US for advanced or metastatic ROS1-positive NSCLC, mentions it has a “manageable tolerability profile” and the many common adverse events including elevations in GGT [48%] and AST [40%] and elevations of ALT above 5 times ULN [3%], but does not mention hepatotoxicity or occurrence of serious, life-threatening, or fatal liver injury). 38279972
Repotrectinib (Augtyro) for non-small cell lung cancer. Med Lett Drugs Ther. 2024;66:e36-e37. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of repotrectinib, mentions hepatotoxicity and that “liver function should be assessed every 2 weeks during the first month of treatment and periodically thereafter”). 38412271
Barbato MI, Bradford D, Ren Y, Aungst SL, Miller CP, Pan L, Zirkelbach JF, et al. FDA approval summary: repotrectinib for locally advanced or metastatic ROS1-positive non-small cell lung cancer. Clin Cancer Res. 2024;30:3364-3370. (Review of the data on efficacy and safety of repotrectinib that supported its FDA approval as therapy for locally advanced or metastatic ROS1-positive NSCLC, mentions that serious adverse reactions occurred in 33% and fatal events in 4.2% of the 264 patients in the safety population; no mention of ALT elevations or hepatotoxicity). 38875108
Desilets A, Repetto M, Yang SR, Drilon A. Targeting ROS1 rearrangements in non-small cell lung cancer: Current insights and future directions. Cancer. 2025;131 Suppl 1: e35784. (Review of the role of ROS1 mutant rearrangements in NSCLC accounting for 1-2% of cases, responding to tyrosine kinase inhibitors targeting ROS1 but with resistant mutations arising after use of first generation inhibitors; ROS1 being an evolutionarily conserved transmembrane protein with an unknown ligand and unclear physiological function, but perhaps by signaling via Ras/Raf/ERK as well as MAPK, PIK3, AKT, mTOR, or STAT3 pathways). 40171848

## OTHER REFERENCE LINKS

1. Recent References on Repotrectinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Repotrectinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Repotrectinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Repotrectinib)